# Exenatide

## OVERVIEW

### Introduction

Exenatide is an analogue of human glucagon-like peptide-1 (GLP-1) which is used in combination with diet and exercise in the therapy of type 2 diabetes, either alone or in combination with other antidiabetic agents. There have been no published reports of hepatotoxicity attributed to exenatide therapy.

### Background

Exenatide (ex en' a tide) is a synthetic analogue of glucagon-like peptide-1 (GLP-1) that acts like the native gastrointestinal hormone (incretin) to increase insulin secretion. Exenatide, like GLP-1, increases insulin secretion by the pancreas and can improve glycemic control in patients with type 2 diabetes. Exenatide is a polypeptide initially extracted from salivary glands of the Gila monster and has close homology (53%) to human GLP-1, but is resistant to DPP-4 degradation and thus has a prolonged duration of activity. Exenatide (also known as exendin-4) must be given parenterally. Exenatide was approved for use in the United States in 2005, and current indications are for the management of glycemic control in adults with type 2 diabetes used in combination with diet and exercise, with or without other oral hypoglycemic agents. Exenatide is available under the brand name Byetta in solution for subcutaneous injection in prefilled pens of 5 or 10 mcg. The typical dose is 5 to 10 mcg twice daily. A long acting form has recently become available under the name Bydureon, which is given subcutaneously in doses of 2 mg once weekly. Exenatide is generally well tolerated, but side effects can include nausea, diarrhea, dizziness, headache, fatigue and rash.

### Hepatotoxicity

Liver injury due to exenatide must be rare, if it occurs at all. In large clinical trials, serum enzyme elevations were no more common with exenatide therapy than with placebo or comparator agents, and no instances of clinically apparent liver injury were reported. Since licensure, there have been no published case reports of hepatotoxicity due to exenatide and the product label does not list liver injury as an adverse event. Exenatide has been linked to rare instances of acute pancreatitis, but even this complication is usually not associated with elevations in serum bilirubin and aminotransferase levels.

### Mechanism of Injury

Exenatide is a hormone-like polypeptide and is metabolized to amino acids by serum and tissue proteases, and is unlikely to have any direct hepatotoxic potential. Exenatide acts through the incretin pathway to affect glucose metabolism and, thus, is often grouped with other incretin-based antidiabetic mediations such as the DPP-4 inhibitors, sitagliptin, saxagliptin and linagliptin and other GLP-1 analogues such as liraglutide, which are also discussed in LiverTox.

References regarding the safety and potential hepatotoxicity of exenatide are given with the Overview section of the GLP-1 Analogues.

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Incretin-Based Drugs, Glucagon-Like Peptide-1 (GLP-1) Analogues: Albiglutide, Dulaglutide, Liraglutide, Lixisenatide, Semaglutide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Exenatide – Byetta®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Exenatide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Exenatide | 141758-74-9 | Protein | Complex Polypeptide

## OTHER REFERENCE LINKS

1. Recent References on Exenatide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Exenatide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Exenatide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Exenatide)